# Red Yeast Rice

## OVERVIEW

### Introduction

Red yeast rice is bright reddish-purple fermented rice which is used as a dietary supplement, predominantly as a cholesterol lowering agent. The reddish-purple color derives from the mold Monascus purpureus. Red yeast rice use has been associated with very rare instances of acute, clinically apparent liver injury.

### Background

Red yeast rice is a traditional Chinese medicine used as an aid to digestion and revitalizing agent. More recently, red yeast rice was shown to have a cholesterol lowering effect and was marketed as a natural means of treating hyperlipidemia. However, chemical characterization of the components of red yeast rice (monascus purpureus) demonstrated the presence of several monacolins, one of which (monacolin K) is chemically identical to lovastatin, a commercially available HMG-coenzyme A inhibitor widely used in the management of hyperlipidemia. While concentrations of lovastatin in commercial preparations of red yeast rice extract are variable, some have pharmacologically active concentrations of lovastatin. Controlled trials have shown that red yeast rice extract can lower total serum and LDL cholesterol. However, these same preparations have also been linked to rare cases of myopathy and liver injury similar to what occurs with lovastatin. Red yeast rice extracts are available over-the-counter in multiple formulations and with variable concentrations of monacolins. The FDA has ruled that red yeast rice extracts that have more than trace amounts of monacolin K (lovastatin) cannot be sold as a dietary supplement, but some products with detectable levels of lovastatin are commercially available. The other components of red yeast rice may have independent effects of lipid levels.

### Hepatotoxicity

In prospective controlled trials, red yeast rice extract formulations have not been associated with serum enzyme elevations or clinically apparent liver injury. However, there have been isolated case reports of liver injury in patients on red yeast rice extracts. A proportion of patients with liver injury attributed to red yeast rice extract were reported to have similar episodes of serum enzyme elevations during conventional lovastatin therapy.

Likelihood score: C (probable rare cause of clinically apparent liver injury).

### Mechanism of Injury

Both the liver injury and myopathies attributed to red yeast rice extracts are probably due to the presence of lovastatin in concentrations of 1 to 10 mg per tablet. Lovastatin is metabolized in the liver via CYP 3A4 and its liver injury is likely due to a toxic or immunogenic metabolite.

### Outcome and Management

The reported cases of liver injury attributed to red yeast rice have been mild-to-moderate in severity and self-limited in course. There have been no cases of acute liver failure or vanishing bile duct syndrome attributed to red yeast rice. Persons with liver injury attributed to red yeast rice extracts should avoid exposure to lovastatin, but switching to other statins may be safe, although it should be done with caution.

Drug Class: Herbal and Dietary Supplements

See also: Lovastatin

## CASE REPORT

### Case 1. Acute hepatitis due to red yeast rice.

[Case from: Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology 2014; 60:1399-408. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/25043597)]

A 67 year old woman with hypercholesterolemia developed abnormal liver tests 7 weeks after starting red yeast rice. She had a history of abnormal liver tests in the past, but routine testing before starting red yeast rice revealed minimal elevations of ALT levels (47 U/L), but normal values for AST, alkaline phosphatase and bilirubin. She did not drink alcohol, had no risk factors for viral hepatitis and no history of drug allergies. Her past medical history included hypertension, aortic valve replacement, hysterectomy, hypothyroidism, osteoporosis and previous urinary tract infections. Her other medications included valsartan, hydrochlorothiazide, low dose aspirin, thyroid extract, multivitamins, calcium, magnesium, zinc and Metamucil, all of which she had taken for more than a year. Laboratory testing initially showed an ALT of 479 U/L, AST 330 U/L, alkaline phosphatase 228 U/L and total bilirubin 0.7. She felt well and had no new symptoms. The red yeast rice was continued and she was followed as an outpatient. Over the next two weeks, however, her liver tests worsened and the red yeast rice was stopped. She subsequently developed fatigue, nausea, dark urine and jaundice (Table). Tests for acute hepatitis A, B, C and E were negative as were routine autoantibodies. Serum albumin ws 4.0 g/dL and globulins 2.3 g/dL. An abdominal ultrasound and CT scan were normal with normal liver size and texture and no evidence of biliary obstruction or masses. She underwent a liver biopsy that showed acute hepatocellular injury without fibrosis, consistent with either a drug induced liver injury or autoimmune hepatitis. She was monitored on no therapy and gradually improved. When seen one year after stopping the botanical product, she was asymptomatic and all liver tests were normal.

#### Key Points

Medication: | Red yeast rice
Pattern: | Hepatocellular (R ratio=6.8)
Severity: | 2+ (jaundice, not hospitalized)
Latency: | 7 weeks
Recovery: | Approximately 4 months
Other medications: | Valsartan, hydrochlorothiazide, aspirin, thyroid extract

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | | 47 | 106 | 0.5
7 weeks | -7 | 479 | 228 | 0.7
8 weeks | 2 days | 864 | 356 | 1.0 | INR 1.0
| 9 days | 1101 | 413 | 0.6 | Liver biopsy
12 weeks | 37 days | 1185 | 290 | 6.3
14 weeks | 48 days | 970 | 294 | 4.2
15 weeks | 55 days | 861 | 169 | 3.5 | INR 1.0
16 weeks | 62 days | 620 | 150 | 2.7
17 weeks | 69 days | 643 | 161 | 3.1
18 weeks | 76 days | 582 | 146 | 3.2
19 weeks | 83 days | 482 | 143 | 4.1
4 months | 90 days | 451 | 154 | 3.7 | INR 1.0
1 year | 1 year | 20 | 106 | 0.8
Normal Values | | <45 | <125 | <1.2

#### Comment

This patient developed an acute hepatitis arising about 2 months after starting red yeast rice for hypercholesterolemia. The hepatitis was mild-to-moderate in severity, but was prolonged which raised the question of autoimmune hepatitis. Against this diagnsosis was the absence of autoantibodies and normal serum globulin levels. She did not receive corticosteroids and ultimately the liver injury resolved. This case was reviewed by an expert causality committee and was judged to be "highly likely" drug induced liver injury from red yeast rice.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Red Yeast Rice – Generic

DRUG CLASS

Herbal and Dietary Supplements

SUMMARY INFORMATION

Fact Sheet at National Center for Complementary and Integrative Health, NIH (https://nccih.nih.gov/health/redyeastrice)

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Red Yeast Rice Monacolin K (Lovastatin) | R400000000 | Unspecified | Not Applicable

## ANNOTATED BIBLIOGRAPHY

References updated: 04 June 2018

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 731-4. (Expert review of hepatotoxicity published in 1999; several herbal medications are discussed, but not red yeast rice).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 631-58. (Review of hepatotoxicity of herbal and dietary supplements [HDS]; red yeast rice is not discussed).
Stedman C. Herbal hepatotoxicity. Semin Liver Dis 2002; 22: 195-206. (Review and description of patterns of liver injury, including discussion of potential risk factors, and herb-drug interactions). 12016550
Keithley JK, Swanson B, Sha BE, Zeller JM, Kessler HA, Smith KY. A pilot study of the safety and efficacy of cholestin in treating HIV-related dyslipidemia. Nutrition 2002; 18: 201-4. (In a controlled trial of cholestin [~5 mg of lovastatin] vs placebo for 8 weeks in 12 patients with hyperlipidemia, there were no changes in "hepatic function"). 11844656
Roselle H, Ekatan A, Tzeng J, Sapienza M, Kocher J. Symptomatic hepatitis associated with the use of herbal red yeast rice. Ann Intern Med 2008; 149: 516-7. (62 year old woman developed fever, nausea and fatigue 4 months after starting red yeast rice extract [ALT 211 U/L, bilirubin and Alk P not given], resolving within several months of stopping). 18838736
Grieco A, Miele L, Pompili M, Biolato M, Vecchio FM, Grattagliano I, Gasbarrini G. Acute hepatitis caused by a natural lipid-lowering product: when "alternative" medicine is no "alternative" at all. J Hepatol 2009; 50: 1273-7. (63 year old woman with ALT elevations after 6 months of lovastatin use, developed fatigue 6 months after starting a cholesterol lowering herbal preparation containing red yeast rice extract [bilirubin 1.9 mg/dL, ALT 1760 U/L, Alk P 722 U/L], resolving over the next 6 months, but with persistence of ALT elevations). 19398239
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 9% of cases were attributed to herbal medications, but no case was attributed to red yeast rice). 18955056
Navarro VJ. Herbal and dietary supplement hepatotoxicity. Semin Liver Dis 2009; 29: 373-382. (Overview of the regulatory environment, clinical patterns, and future directions in research with HDS; red yeast rice is not listed as a potential hepatotoxin). 19826971
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf 2009; 18: 1039-47. (Review of 778 spontaneous reports of adverse reactions to herbals to Swedish Registry; no instance was linked to red yeast rice extracts). 19650152
Becker DJ, Gordon RY, Halbert SC, French B, Morris PB, Rader DJ. Red yeast rice for dyslipidemia in statin-intolerant patients: a randomized trial. Ann Intern Med 2009; 150: 830-9. (Controlled trial of red yeast rice extract vs placebo in 62 patients who had stopped statin therapy because of myalgias, found similar rates of myalgias [7% vs 3%] and no change in ALT or AST levels in both groups). 19528562
Halbert SC, French B, Gordon RY, Farrar JT, Schmitz K, Morris PB, Thompson PD, et al. Tolerability of red yeast rice (2,400 mg twice daily) versus pravastatin (20 mg twice daily) in patients with previous statin intolerance. Am J Cardiol 2010; 105: 198-204. (43 patients with myalgias due to statin use were treated with pravastatin or red rice extract for 24 weeks; discontinuation due to myalgias occurred in 5% on red yeast rice extract and 9% on pravastatin, and mean ALT levels were similar between the 2 groups). 20102918
Venero CV, Venero JV, Wortham DC, Thompson PD. Lipid-lowering efficacy of red yeast rice in a population intolerant to statins. Am J Cardiol 2010; 105: 664-6. (Retrospective analysis of 25 patients who were treated with red yeast rice extract for hyperlipidemia; 2 patients had ALT elevations before treatment, which persisted during follow up, but were never >2 times ULN). 20185013
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury, of which 12 [9%] were due to herbals, including several herbal mixtures, usnic acid, Ma Huang, black cohosh, and Hydroxycut, but not red yeast rice). 20949552
Gordon RY, Cooperman T, Obermeyer W, Becker DJ. Marked variability of monacolin levels in commercial red yeast rice products: buyer beware! Arch Intern Med 2010; 170: 1722-7. (Among 12 red yeast rice extracts commercially available in the US, total monacolin concentrations varied from 0.3-11.1 mg/capsule, monacolin K by 0.1-10.1 mg/capsule, and citrinin [which is nephrotoxic] was present in 4). 20975018
Yang CW, Mousa SA. The effect of red yeast rice(Monascus purpureus) in dyslipidemia and other disorders. Complement Ther Med 2012; 20: 466-74. (Review of literature on efficacy of red yeast rice products found 22 clinical trials; no discussion of safety, ALT elevations or hepatotoxicity). 23131380
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int 2012; 32: 1543-56. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs, herbal drugs and supplements; one implicated red yeast rice [Roselle 2008]). 22928722
Sartore G, Burlina S, Ragazzi E, Ferraresso S, Valentini R, Lapolla A. Mediterranean diet and red yeast rice supplementation for the management of hyperlipidemia in statin-intolerant patients with or without type 2 diabetes. Evid Based Complement Alternat Med 2013; 2013: 743473. Epub 2013 Dec 23. (Among 171 patients with dyslipidemia who were intolerant of statins and were treated with a mediterranean diet with or without red yeast rice for 24 weeks, there was no increase in ALT or AST in any subject). 24454511
Li Y, Jiang L, Jia Z, Xin W, Yang S, Yang Q, Wang L. A meta-analysis of red yeast rice: an effective and relatively safe alternative approach for dyslipidemia. PLoS One 2014; 9: e98611. (Metaanalysis of 13 randomized controlled trials of red yeast rice found that it lowered LDL cholesterol levels, but had no effect on HDL cholesterol, and serum ALT and AST levels were significantly higher with red yeast rice treatment groups). 24897342
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology 2014; 60:1399-408. (Among 85 cases of HDS associated liver injury [not due to anabolic steroids] enrolled in a US prospective study between 2004 and 2013, the single most commonly implicated herbal agent was green tea extract and only one case was exposed to red yeast rice). 25043597
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a prospective database between 2004 and 2012, HDS were implicated in 145 [16%], the single major herbal cause being green tea extract and one case attributed to red yeast rice). 25754159
Red yeast rice: muscle and liver disorders. Prescrire Int 2015; 24: 156. (Between 2009 and 2013, 30 adverse events due to red yeast rice were reported to a French Nutrivigilance Registry, including 9 cases of muscle damage [1 rhabdomyolysis], 8 of liver injury, and 1 of Stevens Johnson syndrome which were attributed to monacolin K found in amounts of 0.1 to 10 mg per tablet). 26436170
García-Cortés M, Robles-Díaz M, Ortega-Alonso A, Medina-Caliz I, Andrade RJ. Hepatotoxicity by dietary supplements: A tabular listing and clinical characteristics. Int J Mol Sci 2016; 17. pii: E537. (Listing of published cases of liver injury from HDS products, does not list red yeast rice).27070596
Mazzanti G, Moro PA, Raschi E, Da Cas R, Menniti-Ippolito F. Adverse reactions to dietary supplements containing red yeast rice: assessment of cases from the Italian surveillance system. Br J Clin Pharmacol 2017; 83: 894-908. (Between 2002 and 2015, 9 cases of drug induced liver injury attributed to red yeast rice were reported to an Italian surveillance system, cases usually arising within 90 days and resolving with stopping; 6 hospitalizations but no deaths ). 28093797
Cicero AFG, Fogacci F, Rosticci M, Parini A, Giovannini M, Veronesi M, D'Addato S, et al. Effect of a short-term dietary supplementation with phytosterols, red yeast rice or both on lipid pattern in moderately hypercholesterolemic subjects: a three-arm, double-blind, randomized clinical trial. Nutr Metab (Lond) 2017; 14: 61. (Among 90 patients with hyperlipidemia treated for 8 weeks, LDL cholesterol levels decreased with red yeast rice but not phytosterols; no mention of adverse events or ALT changes). 29021813
Vega M, Verma M, Beswick D, Bey S, Hossack J, Merriman N, Shah A, et al.; Drug Induced Liver Injury Network (DILIN). The incidence of drug- and herbal and dietary supplement-induced liver injury: preliminary findings from gastroenterologist-based surveillance in the population of the State of Delaware. Drug Saf 2017; 40: 783-7. (A prospective, population based registry of cases of drug induced liver injury occurring in Delaware during 2014, identified 20 cases [2.7 per 100,000] overall, including 6 due to HDS products, all of which were proprietary multiingredient products and none mentioned red yeast rice as a component). 28555362
Brown AC. Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107 (Pt A): 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products, lists one published case linked to red yeast rice [Roselle 2008]). 27402097
Raschi E, Girardi A, Poluzzi E, Forcesi E, Menniti-Ippolito F, Mazzanti G, De Ponti F. Adverse events to food supplements containing red yeast rice: comparative analysis of FAERS and CAERS reporting systems. Drug Saf 2018 Mar 26. [Epub ahead of print] (Analysis of two large US surveillance systems for adverse events reported between 2004 and 2017 found 1459 reports mentioning red yeast rice, only 1% of which were designated a hepatobiliary related; no details provided). 29582393

## OTHER REFERENCE LINKS

1. Recent References on Red Yeast Rice: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Red+Yeastr+Rice)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Red Yeast Rice: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Red+Yeastr+Rice)